# Paliperidone

## OVERVIEW

### Introduction

Paliperidone is a second generation (atypical) antipsychotic agent that is available in both oral and long acting parenteral forms and is used in the treatment of schizophrenia and schizoaffective disorder. Paliperidone is associated with a low rate of serum aminotransferase elevations during therapy, but has not been linked to instances of clinically apparent acute liver injury.

### Background

Paliperidone (pal" ee per' i done) is a second generation antipsychotic agent which appears to act as a dopamine type 2 (D2) partial agonist and post-synaptic antagonist and serotonin (5-HT)-2A receptor antagonist and is similar in structure and mechanism of action to risperidone. Indeed, paliperidone is the primary active metabolite of risperidone, its chemical name being 9-hydroxyrisperidone. Several randomized controlled trials have shown that oral paliperidone improves symptoms of schizophrenia and is comparable in effect to risperidone and ziprasidone. Oral formulations of paliperidone were approved for use in the United States in 2006 as treatment for schizophrenia and schizoaffective disorder, as extended release tablets of 1.5, 3, 6 and 9 mg generically and under the brand name Invega. The recommended maintenance dose is 3 to 12 mg daily, and it is approved for use in adolescents (ages 12 to 17 years) as well as adults. Subsequently, parenteral formulations of paliperidone palmitate were developed that could be administered every one or three months. These palmitate formulations are given intramuscularly in varying doses and are available under the brand names Invega Sustenna and Invega Trinzia. Common side effects of paliperidone include dizziness, dry mouth, somnolence, fatigue, nasal congestion, anxiety, restlessness and weight gain. Paliperidone therapy is also associated with postural hypotension and prolongation of the QTc interval. The intramuscular formulations also can cause local injection site and hypersensitivity reactions. Rare, but potential severe adverse reactions (mentioned in most antipsychotic and antidepressant product labels) include excess mortality in elderly patients with dementia, tardive dyskinesia, major neurologic events, neuroleptic malignant syndrome, thrombotic thrombocytopenic purpura, orthostatic hypotension, prolongation of the QT interval, dyslipidemia, hyperglycemia, seizures and neutropenia.

### Hepatotoxicity

Liver test abnormalities occur in up to 1% of patients receiving paliperidone, but similar rates have been reported with placebo therapy and with comparator agents. The ALT elevations are usually mild, transient and often resolve even without dose modification or drug discontinuation. There have been no published reports of clinically apparent liver injury with symptoms or jaundice attributed solely to paliperidone therapy, even with the long acting parenteral formulations.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which paliperidone might cause serum ALT elevations or liver injury is not known. Paliperidone is metabolized to some extent by the cytochrome P450 system (CYP 2D6 and 3A4), but is an uncommon cause of significant drug-drug interactions with agents that inhibit or induce these microsomal enzymes.

### Outcome and Management

The serum aminotransferase elevations that occur on paliperidone therapy are usually self-limited and often do not require dose modification or discontinuation. No instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome have been attributed to paliperidone. Cross sensitivity to liver related or other hypersensitivity reactions between paliperidone and structurally related antipsychotic agents (such as iloperidone, lurasidone, risperidone and ziprasidone) have not been demonstrated, but may well occur.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Paliperidone – Generic, Invega®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Paliperidone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Paliperidone | 144598-75-4 | C23-H27-F-N4-O3
Risperidone | 106266-06-2 | C23-H27-F-N4-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2023

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
Larry D. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 507-26. (Review of hepatotoxicity of psychiatric agents does not discuss paliperidone).
Canuso CM, Lindenmayer JP, Kosik-Gonzalez C, Turkoz I, Carothers J, Bossie CA, Schooler NR. (2010). A randomized, double-blind, placebo-controlled study of 2 dose ranges of paliperidone extended-release in the treatment of subjects with schizoaffective disorder. J Clin Psychiatry. (Among 316 patients with schizoaffective disorder treated with paliperidone [6 or 12 mg daily] or placebo for 6 weeks, symptom scores improved more with the higher dose paliperidone; adverse events included headache, tremor, somnolence and prolactin elevations, and one patient on paliperidone had “a markedly abnormal elevation” in ALT; no further details provided).
Pandina GJ, Lindenmayer JP, Lull J, Lim P, Gopal S, Herben V, Kusumakar V, et al. (2010). A randomized, placebo-controlled study to assess the efficacy and safety of 3 doses of paliperidone palmitate in adults with acutely exacerbated schizophrenia. J Clin Psychopharmacol. (Among 652 patients with an acute exacerbation of schizophrenia treated with monthly injections of paliperidone [25, 100 or 150 mg equivalents] or placebo for 13 weeks, symptom scores improved more with paliperidone than placebo and “there were no clinically relevant changes from baseline in… clinical laboratory parameters”).
Gopal S, Hough DW, Xu H, Lull JM, Gassmann-Mayer C, Remmerie BM, Eerdekens MH, et al. (2010). Efficacy and safety of paliperidone palmitate in adult patients with acutely symptomatic schizophrenia: a randomized, double-blind, placebo-controlled, dose-response study. Int Clin Psychopharmacol. (Among 388 patients with schizophrenia treated with paliperidone palmitate [50, 100 or 150 mg eq] or placebo by intramuscular injection once monthly, symptom scores improved with the active drug and adverse events included headache, vomiting, pain and injection site reactions; no mention of ALT elevations or hepatotoxicity).
Kramer M, Litman R, Hough D, Lane R, Lim P, Liu Y, Eerdekens M. (2010). Paliperidone palmitate, a potential long-acting treatment for patients with schizophrenia. Results of a randomized, double-blind, placebo-controlled efficacy and safety study. Int J Neuropsychopharmacol. (Among 247 patients with schizophrenia treated with intramuscular paliperidone palmitate or placebo, one patient in the placebo group developed “elevated hepatic enzymes”, but no serious adverse events were liver related).
Emsley R, Berwaerts J, Eerdekens M, Kramer M, Lane R, Lim P, Hough D, Palumbo J. (2008). Efficacy and safety of oral paliperidone extended-release tablets in the treatment of acute schizophrenia: pooled data from three 52-week open-label studies. Int Clin Psychopharmacol. (Among 1083 patients with schizophrenia treated with open label extension studies of paliperidone for 52 weeks, common side effects included insomnia, headache and restlessness [akathisia] and “there were no clinically meaningful changes” in clinical chemistry results).
Meltzer HY, Bobo WV, Nuamah IF, Lane R, Hough D, Kramer M, Eerdekens M. (2008). Efficacy and tolerability of oral paliperidone extended-release tablets in the treatment of acute schizophrenia: pooled data from three 6-week, placebo-controlled studies. J Clin Psychiatry. (Among 1325 patients with acute schizophrenia treated with paliperidone [3-15 mg daily], olanzapine or placebo for 6 weeks in 3 controlled trials, adverse events were more common with the higher doses; no mention of ALT elevations or hepatotoxicity and no liver related serious adverse events reported).
Parsons B, Allison DB, Loebel A, Williams K, Giller E, Romano S, Siu C. (2009). Weight effects associated with antipsychotics: a comprehensive database analysis. Schizophr Res. (Analysis of weight gain in 21 placebo controlled trials [~3300 patients]; average monthly weight gain in pounds was +0.1 with placebo, +0.8 olanzapine, 0.6 risperidone, -0.3 ziprasidone; a 5% increase in weight occurred after one year in 13% of placebo, 39% haloperidol, 20% ziprasidone, 45% risperidone and 60% olanzapine treated subjects; no mention of paliperidone).
Coppola D, Liu Y, Gopal S, Remmerie B, Samtani MN, Hough DW, Nuamah I, Sulaiman A, Pandina G. (2012). A one-year prospective study of the safety, tolerability and pharmacokinetics of the highest available dose of paliperidone palmitate in patients with schizophrenia. BMC Psychiatry. (Among 212 patients with schizophrenia treated with different doses of monthly intramuscular injections of paliperidone palmitate, adverse events included local injection site reactions, nasopharyngitis, insomnia, headache, tachycardia, akathisia, tremor and weight gain; no mention of ALT elevations or hepatotoxicity).
Berwaerts J, Melkote R, Nuamah I, Lim P. (2012). A randomized, placebo- and active-controlled study of paliperidone extended-release as maintenance treatment in patients with bipolar I disorder after an acute manic or mixed episode. J Affect Disord. (Among 756 patients with mania or mixed episodes treated with paliperidone [3-12 mg daily] or olanzapine or placebo, adverse events were most frequent with olanzapine; no mention of ALT elevations or hepatotoxicity).
Citrome L. (2012). Oral paliperidone extended-release: chemistry, pharmacodynamics, pharmakinetics and metabolism, clinical efficacy, safety and tolerability. Expert Opin Drug Metab Toxicol. (Review of the structure, mechanism of action, clinical efficacy and safety of paliperidone as therapy of schizophrenia mentions that adverse events include extrapyramidal symptoms, restlessness, tachycardia, headache, anxiety, somnolence and weight gain, as well as prolongation of the QTc interval; no mention of ALT elevations or hepatotoxicity).
(2013). Drugs for psychiatric disorders. Treat Guidel Med Lett. (Concise review of safety, efficacy and role of drugs for psychiatric disorders mentions that paliperidone is a second generation antipsychotic agent whose adverse side effects include extrapyramidal symptoms, prolactin elevation, nausea, somnolence, dizziness, tachycardia and QTc interval prolongation; no mention of ALT elevations or hepatotoxicity).
Alphs L, Mao L, Rodriguez SC, Hulihan J, Starr HL. (2014). Design and rationale of the Paliperidone Palmitate Research in Demonstrating Effectiveness (PRIDE) study: a novel comparative trial of once-monthly paliperidone palmitate versus daily oral antipsychotic treatment for delaying time to treatment failure in persons with schizophrenia. J Clin Psychiatry. (Description of 15 month trial design to compare one monthly injections of paliperidone to daily oral administration, the end points being time to relapse and safety).
Musil R, Obermeier M, Russ P, Hamerle M. (2015). Weight gain and antipsychotics: a drug safety review. Expert Opin Drug Saf. (Extensive systematic review of the literature on the problem of weight gain during therapy with antipsychotic agents, mentions that weight gain of 7% or more occurs in 0-29% of patients on paliperidone averaging 1.2 kg, the rates being lower than with olanzapine, but higher than with aripiprazole).
Ravenstijn P, Remmerie B, Savitz A, Samtani MN, Nuamah I, Chang CT, De Meulder M, et al. (2016). Pharmacokinetics, safety, and tolerability of paliperidone palmitate 3-month formulation in patients with schizophrenia: A phase-1, single-dose, randomized, open-label study. J Clin Pharmacol. (Among 328 patients with schizophrenia treated with varying doses of a parenteral formulation of paliperidone given every 3 months, common side effects were headache, weight gain and anxiety, but there were “no clinically relevant changes” in chemistry results).
Berwaerts J, Liu Y, Gopal S, Nuamah I, Xu H, Savitz A, Coppola D, et al. (2015). Efficacy and safety of the 3-month formulation of paliperidone palmitate vs placebo for relapse prevention of schizophrenia: a randomized clinical trial. JAMA Psychiatry. (Among 506 patients with schizophrenia treated with a 1- and 3-month formulations of paliperidone or placebo, the most common adverse events were headache, weight gain, nasopharyngitis and restlessness [akathisia: 4%]; the only treatment related early discontinuation was for ALT elevations in a placebo recipient).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology. (Among 899 patients with drug induced liver injury seen over a ten year period at 8 US medical centers, one case was attributed to olanzapine, but none to paliperidone or other atypical antipsychotic medications).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that olanzapine can cause aminotransferase elevations, and that olanzapine and ziprasidone can cause DRESS syndrome, but does not mention ALT elevations or hepatotoxicity for any of agents discussed, including aripiprazole, brexpiprazole, cariprazine, clozapine, quetiapine, risperidone, asenapine, iloperidone, paliperidone and lurasidone).
Chang CH, Lane HY, Liu CY, Chen SJ, Lin CH. (2019). Paliperidone is associated with reduced risk of severe hepatic outcome in patients with schizophrenia and viral hepatitis: A nationwide population-based cohort study. Psychiatry Res. (Analysis of a national health care database found that a cohort of 134 patients with viral hepatitis and schizophrenia who were receiving paliperidone compared to 268 controls matched for age, sex and year enrolled who were receiving other atypical antipsychotics had a lower rate of severe hepatic outcomes [decompensation, liver failure, transplantation or cancer] when matched for age, sex and year enrolled).
Castanheira L, Fernandes E, Levy P, Coentre R. (2019). Aripiprazole-induced hepatitis: a case report. Clin Psychopharmacol Neurosci. (28 year old black woman developed jaundice 21 days after starting aripiprazole [bilirubin 1.1 total, 0.8 mg/dL direct, ALT 745 U/L, Alk P 224 U/L], with resolution within 3 weeks of switching to paliperidone).
Khorassani F, Sousonis F, Lopez LV. (2020). Risperidone- and paliperidone-induced hepatotoxicity: Case report and review of literature. Am J Health Syst Pharm. (23 year old man with schizophrenia developed rising ALT when started on risperidone [ALT 25 to 489 U/L] with no elevations in alkaline phosphatase or AST, which decreased when switched to paliperidone but did not become normal until switched to haloperidol).
Druschky K, Toto S, Bleich S, Baumgärtner J, Engel RR, Grohmann R, Maier HB, et al. (2021). Severe drug-induced liver injury in patients under treatment with antipsychotic drugs: data from the AMSP study. World J Biol Psychiatry. (Among 246 cases of severe liver injury due to antipsychotic medications identified in a prospective registry of German psychiatric hospitals between 1993 and 2016, 46 arose in 38,349 patients [0.12%] who received clozapine [34 as a single antipsychotic agent]; other commonly implicated agents being olanzapine [n=90 of 54,822: 0.16%], quetiapine [34 of 66,209: 0.05%] and risperidone [27 of 51,683: 0.05%]; two fatal cases occurred in olanzapine-treated patients; low rates were found for ziprasidone [no cases among 3568 patients treated] and aripiprazole [6 cases of 15,988 patients treated: 0.01%] paliperidone is not mentioned).
Zeiss R, Hafner S, Schönfeldt-Lecuona C, Connemann BJ, Gahr M. (2022). Drug-associated liver injury related to antipsychotics: exploratory analysis of pharmacovigilance data. J Clin Psychopharmacol. (Review of the VigiBase data base of individual case safety reports on antipsychotics and liver injury found positive hepatic safety signals for olanzapine and clozapine, but not for paliperidone, risperidone, quetiapine, ziprasidone, asenapine, aripiprazole, brexpiprazole, and cariprazine).
Alphs L, Brown B, Turkoz I, Baker P, Fu DJ, Nuechterlein KH. (2022). The Disease Recovery Evaluation and Modification (DREaM) study: Effectiveness of paliperidone palmitate versus oral antipsychotics in patients with recent-onset schizophrenia or schizophreniform disorder. Schizophr Res. (Among 234 adults with recent onset schizophrenia or schizoaffective disorder on oral antipsychotic agents who were either continued on the oral agent or switched to one or three monthly injections of paliperidone for 9 months, the time to relapse was identical in all groups, but became lower with the parenteral drug when patients were then re-randomized; adverse event rates were similar in the two groups except for weight gain which was greater with paliperidone injections [4.8 vs 2.7 kg at 9 months]; no mention of ALT elevations or hepatotoxicity).
Gunther M, Dopheide JA. (2023). Antipsychotic safety in liver disease: a narrative review and practical guide for the clinician. J Acad Consult Liaison Psychiatry. (Review of the literature on hepatotoxicity of antipsychotic medications and guidance on their use in patients with liver disease characterizes chlorpromazine, clozapine, and olanzapine as having the greatest risk for causing liver injury, quetiapine and risperidone as having moderate risk, haloperidol as having low risk, and paliperidone, aripiprazole, lurasidone, loxapine, and ziprasidone as having the lowest risk).
Cicala G, de Filippis R, Barbieri MA, Cutroneo PM, De Fazio P, Schoretsanitis G, Spina E. (2023). Tolerability profile of paliperidone palmitate formulations: A pharmacovigilance analysis of the EUDRAVigilance database. Front Psychiatry. (Analysis of spontaneous adverse event reports related to second generation long acting injectable antipsychotic agents to the European Union Drug Regulating Authorities Vigilance registry between 2011 and 2020 identified 8152 reports attributed to paliperidone, 5,317 risperidone, 4038 aripiprazole, 2802 olanzapine, there was a disproportional rate of sexual and fertility disorders and edema with paliperidone vs other agents, but similar rates of extrapyramidal symptoms and “hepatobiliary disorders” [0.9% vs 1.0% of reports]).
Giron-Hernandez C, Han JH, Alberio R, Singh A, García-Portilla MP, Pompili M, Knight RK, et al. (2023). Efficacy and safety of paliperidone palmitate 6-month versus paliperidone palmitate 3-month long-acting injectable in European patients with schizophrenia: a post hoc analysis of a global phase-3 double-blind randomized non-inferiority study. Neuropsychiatr Dis Treat. (Among 384 patients with schizophrenia stabilized on injectable paliperidone who were treated with either 3-monthly [350 or 525 mg] or 6-monthly [700 or 1000 mg] injections, the 12 month relapse rate was higher but not inferior with the 6-monthly dosing [6.9% vs 2.4%] and adverse event rates were similar in the two groups: no mention of ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Paliperidone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Paliperidone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Paliperidone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Paliperidone)